# Altretamine

## OVERVIEW

### Introduction

Altretamine is an orally administered alkylating agent, formerly known as hexamethylmelamine, which is currently used as a secondary therapy for advanced ovarian carcinoma. Altretamine therapy has been associated with low rates of serum enzyme elevations during therapy and with rare instances of acute, clinically apparent injury.

### Background

Altretamine (al tret' a meen) is a synthetic, orally available alkylating agent belonging to the methylmelamine class of these agents. The alkylating agents act by causing modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis and causing cell death in rapidly dividing cells. Altretamine was approved for use in the United States in 1990. Current indications are advanced ovarian carcinoma in patients who have failed primary therapy with platinum-containing or other alkylating agents. Altretamine is available in capsules of 50 mg under the brand name Hexalen. The recommended dose varies by indication and body surface area and it is typically given orally for 14 to 21 days in 28 day cycles. Altretamine shares common side effects with other alkylating agents such as nausea, vomiting, diarrhea, alopecia, bone marrow suppression, peripheral neuropathy and rash.

### Hepatotoxicity

Altretamine therapy is associated with a low rate of serum enzyme elevations, but these are generally mild and self limited, not requiring dose adjustment. Rare instances of clinically apparent acute liver injury attributed to altretamine have been reported, but the clinical features have not been characterized. Altretamine has not been linked specifically to sinusoidal obstruction syndrome, but it is rarely used in high doses in neoplastic disease or in conditioning regimens for bone marrow transplantation, situations in which alkylating agents are commonly associated with this complication.

Likelihood score: E* (unlikely but suspected rare cause of liver injury).

### Mechanism of Injury

The cause of the idiosyncratic liver injury associated with altretamine use is probably related to a hypersensitivity reaction to a hepatic metabolite of the drug, which is extensively metabolized by the liver.

### Outcome and Management

Liver injury is very rare after altretamine therapy. The severity of injury in reported cases has generally been mild-to-moderate and self limited in course. There have been no instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome definitely linked to chlorambucil therapy. In situations of acute liver injury after altretamine use, rechallenge should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Altretamine – Hexalen®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Altretamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Altretamine | 645-05-6 | C9-H18-N6 | Altretamine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 March 2016

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; triethylenemelamine but not altretamine is discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; altretamine is not discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1315-404. (Textbook of pharmacology and therapeutics).
Ihde DC, Dutcher JS, Young RC, Cordes RS, Barlock AL, Hubbard SM, Jones RB, et al. Phase I trial of pentamethylmelamine: a clinical and pharmacologic study. Cancer Treat Rep 1981; 65: 755-62. (Phase 1 study of a derivative of altretamine in 34 patients with advanced solid tumors given in 1-24 intravenous infusions; 9 patients had elevations in ALT or AST, but no jaundice and most abnormalities occurred in patients with liver metastases). 6791819
Rollins BJ. Hepatic veno-occlusive disease. Am J Med 1986; 8: 297-306. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease [sinusoidal obstruction syndrome: SOS]). 3526887
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing bone marrow transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Manetta A, MacNeill C, Lyter JA, Scheffler B, Podczaski ES, Larson JE, Schein P. Hexamethylmelamine as a single second-line agent in ovarian cancer. Gynecol Oncol 1990; 36: 93-6. (Among 52 patients with advanced ovarian cancer given altretamine in cycles of 14 days, side effects were mainly nausea, vomiting and sensory neuropathy; Alk P elevations occurred in 7 patients, but no details given). 9234915
Ames MM. Hexamethylmelamine: pharmacology and mechanism of action. Cancer Treat Rep 1991; 18: 3-14. (Pharmacology of altretamine demonstrates variable absorption orally, dose related toxicity is nausea and vomiting; activity requires metabolic activation in the liver after which it binds to macromolecules). 1904306
Lee CR, Faulds D. Altretamine: a review of its pharmacodynamic and pharmacokinetic properties, and therapeutic potential in cancer chemotherapy. Drugs 1995; 49: 932-53. (Review of pharmacology, clinical efficacy and safety of altretamine; no mention of hepatotoxicity). 7641606
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of sinusoidal obstruction syndrome after hematopoietic cell transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Malik IA. Altretamine is an effective palliative therapy of patients with recurrent epithelial ovarian cancer. Jpn J Clin Oncol 2001; 31: 69-73. (Among 17 women with recurrent ovarian cancer treated with altretamine for an average of 6 months, toxicity was mainly nausea, vomiting and asthenia; 5 patients developed "Abdominal LFT", but no patient was withdrawn because of toxicity and no details were provided on ALT elevations or hepatotoxicity). 11302345

## OTHER REFERENCE LINKS

1. Recent References on Altretamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Altretamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Altretamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Altretamine)